# Deucravacitinib

## OVERVIEW

### Introduction

Deucravacitinib is a small molecule inhibitor of tyrosine kinase 2 that is used in the treatment of moderate-to-severe plaque psoriasis. Deucravacitinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy but has not been linked instances of clinically apparent acute liver injury.

### Background

Deucravacitinib (deu krav” a sye’ ti nib) is an orally available, small molecular inhibitor of tyrosine kinase 2 (TYK2) that is used to treat moderate-to-severe plaque psoriasis. TYK2 is a non-receptor tyrosine kinase and a member of the JAK kinase family, which are critical components of pathways that lead to production and secretion of hematologic growth factors and inflammatory cytokines. These pathways are important in hematologic cell differentiation and proliferation, intracellular signaling by interferon alpha and gamma, and in cytokine-production and inflammatory reactions. Inhibition of TYK2 leads to decreases in expression of IL23, type 1 interferon, and beta defensin. Patients with psoriasis frequently have raised levels of cytokines that are modulated by TYK2, such as IL23, IL17, and type 1 interferon, and which are decreased by deucravacitinib therapy. Deucravacitinib has been shown to improve symptoms and rash in patients with plaque psoriasis and was approved in the United States in 2023 for adults with moderate-to-severe plaque psoriasis who are candidates for systemic or phototherapy. Deucravacitinib is available in tablets of 6 mg under the brand name Sotyktu. The recommended dose is 6 mg once daily. Common side effects include symptoms of upper respiratory infection, mouth ulcers, folliculitis, acne, herpes simplex, and creatine phosphokinase (CPK) elevations. Less common but potentially severe adverse events include hypersensitivity reactions, risk of infections including reactivation of tuberculosis, rhabdomyolysis, and malignancies. It is suspected that TYK2 inhibitors share the long term adverse events found with JAK inhibitors, which include increased risk of major cardiovascular adverse events, serious infections, venous and arterial thromboses, secondary malignancies, and overall mortality.

### Hepatotoxicity

In the preregistration clinical trials of deucravacitinib that included data on 1519 subjects, only 1.8% of patients had serum ALT or AST elevations above 5 times ULN, none of which were considered likely due to drug induced liver injury, with myositis accounting for many of the elevations, and underlying alcoholic or nonalcoholic fatty liver disease accounting for a few. Elevations of ALT levels above 3 times the ULN arose in 1.1% to 1.3% of recipients of deucravacitinib in a 24 week trial compared to 1.2% of placebo recipients. While there were no instances of reactivation of hepatitis B in patients receiving deucravacitinib, patients with preexisting HBsAg in serum were excluded from enrollment and most treatment courses were limited in duration. Since its approval and more widespread clinical use, there have been no further reports of clinically apparent liver injury attributed to deucravacitinib, but it has been available for a limited time only.

Likelihood score: E (suspected but unproven cause of clinically apparent liver injury including reactivation of hepatitis B).

### Mechanism of Injury

Deucravacitinib therapy is associated with only a low rate of serum enzyme elevations and the mechanisms by which it might cause liver injury are unknown. It is metabolized in the liver largely by CYP 1A2 and to a lesser extent by CYP 2B6, 2D6, carboxylesterase 2, and uridine glucuronyl transferase. However, deucravacitinib neither induces nor inhibits these metabolizing enzymes, and it has not been found to have clinically significant drug-drug interactions. Because of its effects on intracellular signaling involved in immune responses, deucravacitinib (and other JAK inhibitors) may be capable of increasing hepatitis B viral replication which might result in clinically apparent reactivation of hepatitis B.

### Outcome and Management

Deucravacitinib has been associated with a low rate of serum aminotransferase elevations. The product label recommends evaluation of routine liver tests at baseline and thereafter as needed for patient management or if liver disease is suspected. Serum aminotransferase elevations above 3 times ULN should lead to interruption until the diagnosis of drug induced liver injury can be excluded. ALT or AST elevations above 20 times ULN or any elevations accompanied by jaundice or symptoms should lead to prompt discontinuation. Because of the possibility of reactivation of hepatitis B, it is appropriate to screen patients for hepatitis B markers before starting deucravacitinib and, if HBsAg or anti-HBc are present, providing antiviral prophylaxis or monitoring for reactivation during therapy. There does not appear to be cross reactivity in risk for hepatic injury among the various JAK and TYK2 kinase inhibitors, but few instances have been studied.

Drug Class: Dermatologic Agents, Psoriasis Agents (https://www.ncbi.nlm.nih.gov/books/n/livertox/PsoriasisDrugs/), Protein Kinase Inhibitors

Janus Kinase Inhibitors: Abrocitinib, Baricitinib, Fedratinib, Momelotinib, Pacritinib, Ritlecitinib, Ruxolitinib, Tofacitinib, Upadacitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Deucravacitinib – Sotyktu®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Deucravacitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Deucravacitinib | 1609392-27-9 | C20-H19-D3-N8-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 28 December 2023

Abbreviations: JAK, Janus kinase; STAT, signal transducer activator of transcription; TYK2, Tyrosine Kinase 2.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as deucravacitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not deucravacitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/214958Orig1s000MultidisciplineR.pdf (Integrated FDA review of the data on safety and efficacy of deucravacitinib that formed the basis of its approval mentions that, in a 24-week controlled trial of deucravacitinib, ALT elevations above 3 times ULN arose at a rate of 3.6 per patient year of exposure, and that analysis of the total safety cohort of 1519 patients identified 24 instances of ALT or AST elevations above 5 times ULN, most of which were transient and unrelated and none of which on thorough evaluation were considered due to drug induced liver injury).
Chimalakonda A, Burke J, Cheng L, Catlett I, Tagen M, Zhao Q, Patel A, et al. Selectivity profile of the tyrosine kinase 2 inhibitor deucravacitinib compared with Janus kinase 1/2/3 inhibitors. Dermatol Ther (Heidelb). 2021;11:1763–1776. (Among JAK kinase inhibitors, deucravacitinib binds to a regulatory rather than catalytic site on TYK2, which gives it a high selectivity so that it has little or no activity against JAK1, JAK2 or JAK3, and pilot studies suggest that it has fewer adverse side effects and is less likely to affect serum aminotransferase levels compared to other JAK kinase inhibitors). 34471993
Armstrong AW, Gooderham M, Warren RB, Papp KA, Strober B, Thaçi D, Morita A, et al. Deucravacitinib versus placebo and apremilast in moderate to severe plaque psoriasis: efficacy and safety results from the 52-week, randomized, double-blinded, placebo-controlled phase 3 POETYK PSO-1 trial. J Am Acad Dermatol. 2023;88:29–39. (Among 666 adults with plaque psoriasis treated with deucravacitinib [6 mg daily], apremilast [30 mg twice daily] or placebo for 16 weeks, symptomatic scores improved in 58% vs 54% vs 7-12% on placebo, while overall adverse events were similar in the 3 groups but serious adverse events were less with deucravacitinib [2.1% vs 5.5% with placebo] and mean serum ALT levels did not change in any group). 35820547
Strober B, Thaçi D, Sofen H, Kircik L, Gordon KB, Foley P, Rich P, et al. Deucravacitinib versus placebo and apremilast in moderate to severe plaque psoriasis: efficacy and safety results from the 52-week, randomized, double-blinded, phase 3 program for evaluation of TYK2 inhibitor psoriasis second trial. J Am Acad Dermatol. 2023;88:40–51. (Abstract only: Among 1020 adults with moderate to severe plaque psoriasis treated with deucravacitinib [6 mg daily], apremilast [30 mg twice daily], or placebo for up to 52 weeks, 16 week-clinical response rates were highest with deucravacitinib [49.5% vs 33.9% vs 8.6%], and efficacy was maintained to 52 weeks, while adverse events were mostly mild and transient, and serious adverse events and discontinuations were “infrequent”). 36115523
Morand E, Pike M, Merrill JT, van Vollenhoven R, Werth VP, Hobar C, Delev N, et al. Deucravacitinib, a tyrosine kinase 2 inhibitor, in systemic lupus erythematosus: a phase II, randomized, double-blind, placebo-controlled trial. Arthritis Rheumatol. 2023;75:242–252. (Among 363 adults with systemic lupus erythematosus treated with deucravacitinib [3 or 6 mg twice daily or 12 mg once daily] vs placebo for 48 weeks, symptomatic response rates were higher with deucravacitinib [58% vs 30%], while overall adverse event rates were similar [84% to 93% vs 88%] as were severe adverse events [7.7% to 8.6% vs 12.2%] and discontinuations [6.5% to 12.4% vs 3.3%]; mean ALT levels did not change, and there were no discontinuations for enzyme elevations in treated patients). 36369798
Deucravacitinib (Sotyktu) for plaque psoriasis. Med Lett Drugs Ther. 2023;65:29–31. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of deucravacitinib shortly after its approval as therapy of psoriasis in 2023, mentions that serum enzyme elevations have occurred in patients taking deucravacitinib). 36757835
Truong TM, Pathak GN, Singal A, Taranto V, Rao BK. Deucravacitinib: The first FDA-approved oral TYK2 inhibitor for moderate to severe plaque psoriasis. Ann Pharmacother. 2023;•••:10600280231153863. (Summary of the efficacy and safety of deucravacitinib mentions that adverse events appear to be less common than with JAK kinase inhibitors, with an adverse event rate of 75%, only 4% serious, and 3-4% requiring discontinuation, known adverse events being hypersensitivity reactions, infections [29%], viral reactivation [herpes simplex 2% and zoster <1%], tuberculosis [<1%], lymphoma [<1%], liver function test abnormalities [2%], but no mention of hepatotoxicity or clinically apparent liver injury).

## OTHER REFERENCE LINKS

Recent References on Deucravacitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Deucravacitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Deucravacitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Deucravacitinib)